# Selinexor

## OVERVIEW

### Introduction

Selinexor is a small molecule inhibitor of a nuclear exporter of proteins which is used in combination with dexamethasone in the therapy of adults with relapsed or refractory multiple myeloma. Selinexor is associated with a low rate of transient serum enzyme elevation during therapy but has not been linked to cases of clinically apparent liver injury with jaundice.

### Background

Selinexor (sel” in nex’ or) is a small molecule inhibitor of nuclear exportin-1 (XPO1) which blocks the transport of tumor suppressor proteins, oncoproteins, and growth regulators such as c-myc and cyclin D1 from the nucleus into the cytoplasm. This results in cell cycle arrest and apoptosis of cancerous but not noncancerous cells. Selinexor therapy was found to result in prolongation of progression-free survival in highly pretreated patients with advanced, relapsed or refractory multiple myeloma. Selinexor was approved for use in the United States in 2019, with indications limited to adults with relapsed or refractory multiple myeloma after failure of at least 4 previous treatment regimens. Selinexor is available tablets of 20, 40, 50 and 60 mg under the brand name Xpovio. The recommended initial dose is 80 mg on days 1 and 3 each week to continue with subsequent dose adjustment based upon tolerance. Selinexor should be used in combination with dexamethasone and with careful monitoring for side effects, platelet counts and white counts. Common side effects include neutropenia, thrombocytopenia, anemia, nausea, vomiting, anorexia, weight loss, weakness, fatigue, hyponatremia, headaches, dizziness, and confusion. Rare, but potentially serious side effects include severe hematologic toxicities including thrombocytopenia and neutropenia, severe infections, acute neurotoxicity, and embryo-fetal toxicity.

### Hepatotoxicity

In prelicensure open label trials of selinexor in a total of 202 patients with advanced, refractory or relapsed multiple myeloma, serum ALT elevations arose in 8.4% of treated subjects and were above 5 times the ULN in 2.5%. The timing and character of the elevations were not described, but no patient developed raised serum enzymes with jaundice or symptoms. Since approval and general availability of selinexor, there have been no published reports of clinically apparent liver injury attributed to its use.

Likelihood score: E* (unproven, but possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the serum enzyme and bilirubin elevations that occur during selinexor therapy is unknown. Selinexor is metabolized in the liver predominantly by CYP 3A4 but does not inhibit or induce the enzyme. Its use with strong inducers of CYP 3A4 could result in decreased drug levels and reduced efficacy, while use with strong CYP 3A4 inhibitors could result in elevated drug levels and potentially increased adverse events.

### Outcome and Management

The elevations in serum ALT and bilirubin during selinexor therapy have been asymptomatic, mild and transient, not requiring dose adjustments. Routine monitoring of liver tests is not recommended. There is no information on cross sensitivity for hepatic injury between selinexor and other medications used in the therapy of multiple myeloma.

Drug Class: Antineoplastic Agents, Multiple Myeloma Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Selinexor – Xpovio®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Selinexor)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Selinexor | 1393477-72-9 | C17-H11-F6-N7O

## ANNOTATED BIBLIOGRAPHY

SELECTED BIBLIOGRAPHY

References updated: 29 April 2023

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 before the availability of selinexor).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam, Elsevier, 2013, p. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; selinexor is not discussed).
Isaacs C, Wellstein A, Riegel AT. Hormones and related agents in the therapy of cancer. Natural products in cancer chemotherapy: hormones and related agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1237-48. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/212306Orig1s000MultidisciplineR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that ALT elevations arose in 8.4% of treated patients and were above 5 times the ULN in 2.5% but no patient developed jaundice or symptoms of acute liver injury).
Grosicki S, Simonova M, Spicka I, Pour L, Kriachok I, Gavriatopoulou M, Pylypenko H, et al. (2020). Once-per-week selinexor, bortezomib, and dexamethasone versus twice-per-week bortezomib and dexamethasone in patients with multiple myeloma (BOSTON): a randomised, open-label, phase 3 trial. Lancet. (Among 402 adults with relapsed or refractory multiple myeloma treated with bortezomib and dexamethasone with or without selinexor [100 mg once weekly], progression-free survival was longer with addition of Selinexor [13.2 vs 9.5 months]; no mention of ALT elevations or hepatotoxicity).
Azmi AS, Uddin MH, Mohammad RM. (2021). The nuclear export protein XPO1 – from biology to targeted therapy. Nat Rev Clin Oncol. (Description of the nuclear export proteins, their role in cell integrity, and the development of specific small molecular inhibitors and their possible therapeutic activities).
Kalakonda N, Maerevoet M, Cavallo F, Follows G, Goy A, Vermaat JSP, Casasnovas O, et al. (2020). Selinexor in patients with relapsed or refractory diffuse large B-cell lymphoma (SADAL): a single-arm, multinational, multicentre, open-label, phase 2 trial. Lancet Haematol. (Among 175 adults with relapsed or refractory diffuse large cell B cell lymphoma treated with selinexor [60 mg on days 1 and 3 weekly], the overall response rate was 28% and adverse events included thrombocytopenia, anemia, neutropenia, fatigue, and nausea, but there were no drug related deaths and no liver related severe adverse events; no mention of ALT elevations).
Chari A, Vogl DT, Gavriatopoulou M, Nooka AK, Yee AJ, Huff CA, Moreau P, et al. (2019). Oral selinexor-dexamethasone for triple-class refractory multiple myeloma. N Engl J Med. (Among 122 adults with relapsed or refractory multiple myeloma treated with selinexor [80 mg twice weekly], 26% had at least a partial response, the median progression-free survival was 3.7 months and overall survival 8.6 months, while side effects were frequent including thrombocytopenia [73%], anemia [62%], neutropenia [40%], fatigue [73%], nausea [72%], decreased appetite [56%], weight loss [50%], diarrhea [46%], and hyponatremia [37%]; no mention of ALT elevations or hepatotoxicity).
Syed YY. (2019). Selinexor: first global approval. Drugs. (Review of the mechanism of action, history of development, pharmacokinetics, clinical efficacy, and safety of Selinexor, the first-in-class, oral, small molecule inhibitor of nuclear Exportin-1; no mention of hepatotoxicity or serum ALT elevations during therapy).

## OTHER REFERENCE LINKS

1 Recent References on Selinexor: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Selinexor+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Selinexor: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Selinexor)